# Siponimod

## OVERVIEW

### Introduction

Siponimod is an orally available sphingosine-1-phosphate (S1P) receptor modulator that acts as an immunomodulatory drug and is used to treat relapsing forms of multiple sclerosis. Siponimod is associated with transient serum enzyme elevations during therapy but has not been linked to instances of clinically apparent liver injury with jaundice.

### Background

Siponimod (si pon’ i mod) is an orally available sphingosine-1-phosphate (S1P) receptor modulator that is used to treat relapsing forms of multiple sclerosis. Siponimod is a derivative of myriocin, a metabolite of the fungus Isaria sinclairii and is a structural analogue of sphingosine. Similar to fingolimod, the first S1P receptor modulator approved for use in multiple sclerosis, siponimod appears to have greater selectivity of S1P receptors 1 and 5, and thus might have equivalent potency to fingolimod but fewer off-target side effects. Once phosphorylated intracellularly, siponimod acts as a S1P receptor modulator which renders T and B cells insensitive to signals necessary for egress from lymphoid tissue. In animal models of multiple sclerosis, siponimod resulted in reduced recirculation of autoaggressive lymphocytes to the central nervous system. Subsequently, in several large, randomized controlled trials, siponimod was shown to reduce relapse rates and improve neuro-radiologic outcomes in adult patients with relapsing multiple sclerosis. Siponimod was approved for use in the United States in 2019 and is available in tablets of 0.25, 1, and 2 mg under the brand name Mayzent. Like with other S1P receptor modulators, an initial titration period (5 days) is recommended for initiation of therapy to achieve a maintenance dose in adults of 2 mg orally once daily. Common side effects of siponimod are lymphopenia, headache, diarrhea, cough, dyspnea, hypertension, rhinorrhea and back and abdominal pain. Rare, but potentially severe adverse events include severe viral, bacterial or fungal infections, atrial arrhythmias and bradycardia, macular edema, decrease in pulmonary function, progressive multifocal leukoencephalopathy (PML), and embryonal-fetal toxicity.

### Hepatotoxicity

In large controlled trials of siponimod in patients with multiple sclerosis, serum ALT elevations were common, typically arising during the first 3 months of treatment. The elevations were generally mild and asymptomatic, and they often returned to baseline values even with continuation of treatment or within 3 months of stopping. Aminotransferase elevations above 3 times upper limit of normal (ULN) were reported in 6% to 8% of siponimod recipients compared to less than 2% of placebo recipients. In these prelicensure clinical trials, there were no cases of acute hepatitis or clinically apparent liver injury but elevations in liver tests led to discontinuation in 1% if subjects. While siponimod is associated with lymphopenia and long term therapy is associated with risk for reactivation of herpes simplex and zoster infections, it has not been linked to cases of reactivation of hepatitis B, although one such instance has been reported with fingolimod. Thus, mild-to-moderate and transient serum enzyme elevations during therapy are not uncommon, but clinically apparent liver injury with jaundice due to siponimod must be rare if it occurs at all.

Likelihood score: E* (suspected but unproven cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which siponimod might cause liver injury is not known. It is extensively metabolized in the liver; an injury might be mediated by intermediates of its metabolism. Siponimod is metabolized via the cytochrome P450 system, predominantly CYP 2C9 and 3A4 and drug-drug interactions with agents that induce or inhibit these enzymes are likely to occur.

### Outcome and Management

While chronic therapy with siponimod can be associated with mild-to-moderate serum aminotransferase elevations, it has not been linked to any cases of clinically apparent liver injury. Because of the frequency of enzyme elevations detected during therapy, the product label for siponimod recommends obtaining baseline liver tests before initiation of treatment. However, no specific recommendations for monitoring liver tests during treatment have been made. There is no known cross sensitivity of the hepatic injury from siponimod with other agents used to treat multiple sclerosis. Because of the similarity in chemical structure and mechanism of action, there may be cross sensitivity to side effects with fingolimod, ozanimod or ponesimod.

Drug Class: Multiple Sclerosis Agents

Other Drugs in the Subclass, S1P Receptor Modulators: Fingolimod, Ozanimod, Ponesimod

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Siponimod – Mayzent®

DRUG CLASS

Multiple Sclerosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=44492772-5aed-4627-bd85-e8e89f308bb3)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Siponimod | 1230487-00-9 | C29-H35-F3-N2-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 25 November 2025

Abbreviations: HBV, hepatitis B virus; S1P, sphingosine-1-phosphate.

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 697-8. (Expert review of hepatotoxicity published in 1999 before the availability of siponimod).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013 does not discuss the drugs for multiple sclerosis).
Krensky AM, Azzi JR, Hafler DA. Immunotherapy for multiple sclerosis. Immunosuppressants and Tolerogens. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 649-52. (Textbook of pharmacology and therapeutics).
FDA: Center for Drug Evaluation and Research. 209884Orig1s000. Clinical Review(s). pp: 166-73. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/209884Orig1s000MedR.pdf (FDA website with product labels and medical review of the efficacy and safety of siponimod; mentions that serum aminotransferase elevations are common during siponimod therapy occurring in almost half of patients but are typically mild and resolve rapidly with stopping, and that serious hepatotoxicity was not encountered; ALT elevations above 3 times the ULN occurred in 6-8% of subjects).
Kappos L, Radue EW, O'Connor P, Polman C, Hohlfeld R, Calabresi P, Selmaj K, et al.; FREEDOMS Study Group. A placebo-controlled trial of oral fingolimod in relapsing multiple sclerosis. N Engl J Med 2010; 362: 387-401. (Among 1272 patients with relapsing multiple sclerosis treated with fingolimod [0.5 or 1.25 mg daily] or placebo for 24 months, 8.5-12.5% of fingolimod, but only 1.7% of placebo recipients developed ALT elevations above 3 times ULN, and ALT levels fell to normal with or without discontinuation, and serum bilirubin levels did not change). 20089952
Cohen JA, Barkhof F, Comi G, Hartung HP, Khatri BO, Montalban X, Pelletier J, et al.; TRANSFORMS Study Group. Oral fingolimod or intramuscular interferon for relapsing multiple sclerosis. N Engl J Med 2010; 362: 402-15. (Among 1280 patients with relapsing multiple sclerosis treated with fingolimod [0.5 or 1.25 mg daily] or interferon beta [30 mg weekly] for 12 months, relapse rates were lower, but ALT elevations above 3 times ULN were more common with fingolimod [7% and 8%] than interferon beta [2%], although there were no clinically apparent episodes of liver injury). 20089954
Oral fingolimod (gilenya) for multiple sclerosis. Med Lett Drugs Ther 2010; 52 (1353-1354): 98-9. (Concise review of mechanism of action, efficacy, safety and costs of fingolimod shortly after is approval for use for multiple sclerosis in the US, mentions that common side effects are headache, cough, diarrhea, back pain and aminotransferase elevations; no mention of clinically apparent liver injury). 21344782
New drugs for relapsing multiple sclerosis. Med Lett Drugs Ther 2012; 54(1403): 89-91. (Concise review of efficacy, safety and costs of new disease modifying drugs for multiple sclerosis lists side effects in a table including "transaminase elevations" for interferon beta, fingolimod and teriflunomide and "hepatotoxicity" for natalizumab, but not for glatiramer or mitoxantrone). 23183318
Oh J, O'Connor PW. Safety, tolerability, and efficacy of oral therapies for relapsing-remitting multiple sclerosis. CNS Drugs 2013; 27: 591-609. (Review of efficacy and safety or oral agents for multiple sclerosis, including fingolimod, teriflunomide, dimethyl fumarate, laquinimod and cladribine, none of which have raised major issues of hepatotoxicity). 23801528
Kappos L, O’Connor P, Radue E-W, Polman C, Hohlfeld R, Selmaj K, Ritter S, et al. Long-term effects of fingolimod in multiple sclerosis: the randomized FREEDOMS extension trial. Neurology 2015; 84: 1582-91. (Among 920 patients with multiple sclerosis enrolled in an extension study of fingolimod [0.5 vs 1.25 mg daily], beneficial effects were sustained and no new safety concerns arose, serum enzyme elevations occurring in 13% and 19% of subjects during the first and 7% and 8% during the second year of fingolimod therapy). 25795646
Selmaj K, Li DK, Hartung HP, Hemmer B, Kappos L, Freedman MS, Stüve O, et al. Siponimod for patients with relapsing-remitting multiple sclerosis (BOLD): an adaptive, dose-ranging, randomised, phase 2 study. Lancet Neurol 2013; 12: 756-67. (Among 297 patients with relapsing multiple sclerosis treated with siponimod [0.25, 0.50,1.25, 2 or 10 mg] or placebo once daily for 6 months, there was a dose related increase in clinical responses and higher rates of adverse events including ALT elevations [0% to 6-8%], but levels were rarely above 3 times ULN and there were no hepatic serious adverse events). 23764350
English C, Aloi JJ. New FDA-approved disease-modifying therapies for multiple sclerosis. Clin Ther 2015; 37: 691-715. (Systematic review of efficacy and safety of the newer disease modifying therapies of multiple sclerosis lists ALT elevations as adverse events associated with fingolimod, teriflunomide and dimethyl fumarate, but not peginterferon beta or alemtuzumab). 25846320
Subei AM, Cohen JA. Sphingosine 1-phosphate receptor modulators in multiple sclerosis. CNS Drugs 2015; 29: 565-75. (Review of the function of the S1P receptors [subtypes 1 to 5] and the clinical implications of their differential modulation by different inhibitors). 26239599
Kappos L, Li DK, Stüve O, Hartung HP, Freedman MS, Hemmer B, Rieckmann P, et al. Safety and Efficacy of siponimod (BAF312) in patients with relapsing-remitting multiple sclerosis: dose-blinded, randomized extension of the phase 2 BOLD study. JAMA Neurol 2016; 73: 1089-98. (Among 252 patients with relapsing multiple sclerosis continued in an extension of a phase 2 study of siponimod [Selmaj 2013], there was a dose related increase in frequency of ALT elevations [2% to 17%] but there were no hepatic serious adverse events). 27380540
Hammond ER. Perspectives on safety and efficacy-the BOLD phase 2 extension study of siponimod in relapsing-remitting multiple sclerosis. JAMA Neurol 2016; 73: 1052-4. (Editorial in response to the analyses of efficacy and safety of siponimod in an extension study [Kappos 2016]). 27380179
Shakeri-Nejad K, Aslanis V, Veldandi UK, Gardin A, Zaehringer A, Dodman A, Su Z, et al. Pharmacokinetics, safety, and tolerability of siponimod (BAF312) in subjects with different levels of hepatic impairment: a single-dose, open-label, parallel-group study. Int J Clin Pharmacol Ther 2017; 55: 41-53. (Single dose studies of siponimod done in 40 subjects found little difference in pharmacokinetics among patients with or without hepatic impairment). 27443658
Filippi M, Bar-Or A, Piehl F, Preziosa P, Solari A, Vukusic S, Rocca MA. Multiple sclerosis. Nat Rev Dis Primers 2018; 4: 43. (Review of the pathogenesis, clinical features, natural history, management and therapy of multiple sclerosis). 30410033
Kappos L, Bar-Or A, Cree BAC, Fox RJ, Giovannoni G, Gold R, Vermersch P, et al.; EXPAND Clinical Investigators. Siponimod versus placebo in secondary progressive multiple sclerosis (EXPAND): a double-blind, randomised, phase 3 study. Lancet 2018; 391(10127): 1263-73. (Among 1645 patients with secondary progressive multiple sclerosis enrolled in a controlled trial for up to 3 years, disability progression was less frequent with siponimod than placebo [26% vs 32%] but liver related “investigations” were more common [12% vs 4%] as were ALT elevations [6% vs 2%], although few were above 5 times ULN [0.9% vs 0.4%] and none resulted in clinically apparent liver injury with jaundice ). 29576505
Jin Y, Borell H, Gardin A, Ufer M, Huth F, Camenisch G. In vitro studies and in silico predictions of fluconazole and CYP2C9 genetic polymorphism impact on siponimod metabolism and pharmacokinetics. Eur J Clin Pharmacol 2018; 74: 455-64. (In vitro metabolic studies using human liver microsomes demonstrated possible functional consequences of CYP2C9*2/*2 and CYP2C9*3/*3 polymorphisms on the metabolism of siponimod which predict significant reductions in clearance and possible drug accumulation to toxic levels). 29273968
Siponimod (Mayzent)--a new drug for multiple sclerosis. Med Lett Drugs Ther 2019; 61(1571): 70-2. (Concise review of the mechanism of action, clinical efficacy, safety and costs of siponimod in comparison to other agents used to treat multiple sclerosis; mentions that serum aminotransferase elevations can occur with siponimod therapy and that patients should be tested for liver function tests and have CYP 2C9 genotype testing before starting treatment). 31169805
Al-Salama ZT. Siponimod: First global approval. Drugs 2019; 79: 1009-15. (Review of the mechanism of action, history of development, clinical efficacy and safety of siponimod; mentions the common side effects include headache, hypertension, aminotransferase elevations, peripheral edema, nausea, dizziness, diarrhea, bradycardia and musculoskeletal pain but that the aminotransferase levels were rarely severely elevated). 31144287
Lu MC, Shih YL, Hsieh TY, Lin JC. Flare of hepatitis B virus after fingolimod treatment for relapsing and remitting multiple sclerosis. J Formos Med Assoc 2020; 119: 886-7. (Letter describing 41 year old Taiwanese woman with relapsing multiple sclerosis and inactive HBsAg carrier state who developed reactivation of hepatitis B after 35 months of treatment with fingolimod [ALT 385 U/L, HBV DNA 8 log_10_ IU/mL, bilirubin not given], who responded to tenofovir with resolution of ALT elevations and decrease of HBV DNA levels to undetectable despite continuation of fingolimod). 31679907
Drugs for multiple sclerosis. Med Lett Drugs Ther 2021; 63(1620): 42-8. (Concise review of the relative clinical efficacy, safety and costs of drugs for relapsing multiple sclerosis including parenteral agents [such as interferon-beta, glatiramer acetate, natalizumab, alemtuzumab, ocrelizumab, ofatumumab, rituximab and mitoxantrone] and the oral agents [such as the S1P receptor modulators, cladribine, fumarates, and teriflunomide], many of which are associated with serum ALT elevations and several have been reported to cause clinically apparent liver injury or reactivation of hepatitis B). 33976089
McGinley MP, Cohen JA. Sphingosine 1-phosphate receptor modulators in multiple sclerosis and other conditions. Lancet 2021;398:1184-94.. (Review of the function of S1P receptors and the mechanism of action of S1P receptor modulators in affecting lymphocyte tracking out of lymph nodes into the circulation and tissues; fingolimod is a nonspecific modulator affecting S1P receptors 1, 3, 4 and 5, whereas siponimod and ozanimod act predominantly on S1P receptors 1 and 5 and ponesimod against S1P receptor 1 alone, the activity against S1P receptor-1 accounting for most of the beneficial effects in multiple sclerosis and the restricted specificity perhaps accounting for the lower rate of cardiac, lung and eye adverse events driven mostly by the inhibition of the other S1P receptor subtypes). 34175020
Biolato M, Bianco A, Lucchini M, Gasbarrini A, Mirabella M, Grieco A. The disease-modifying therapies of relapsing-remitting multiple sclerosis and liver injury: a narrative review. CNS Drugs. 2021;35:861-880.. (Extensive review of the frequency and characteristics of hepatic injury associated with different disease modifying drugs for multiple sclerosis, discusses fingolimod but not siponimod). 34319570
Cree BA, Arnold DL, Fox RJ, Gold R, Vermersch P, Benedict RH, Bar-Or A, et al. Long-term efficacy and safety of siponimod in patients with secondary progressive multiple sclerosis: Analysis of EXPAND core and extension data up to >5 years. Mult Scler. 2022;28:1591-1605.. (Among 1220 patients with multiple sclerosis treated in a controlled trial [Kappos 2018] who were then treated with open label siponimod for up to 3 years, rates of continued disease progression and adverse event were similar to those in the active period of the previous trial and there were “no new safety signals”; elevations in aminotransferase levels arose in 0.3%). 35380078
Gold R, Piani-Meier D, Kappos L, Bar-Or A, Vermersch P, Giovannoni G, Fox RJ, et al. Siponimod vs placebo in active secondary progressive multiple sclerosis: a post hoc analysis from the phase 3 EXPAND study. J Neurol. 2022;269:5093-5104.. (A secondary analysis of results from a controlled trial of siponimod vs placebo in adults with multiple sclerosis [Kappos 2018] reported that adverse events arose in 86.8% vs 78.3%, serious adverse events of 15.1% vs 15.6%, and ALT elevations in 6.6% vs 2.3% which were serious in 1.2% vs 0.8%). 35639197
Regner-Nelke L, Pawlitzki M, Willison A, Rolfes L, Oezalp SH, Nelke C, Kölsche Tet al. Real-world evidence on siponimod treatment in patients with secondary progressive multiple sclerosis. Neurol Res Pract. 2022;4:55.. (Among 227 patients with multiple sclerosis treated in 12 German referral centers with siponimod [1 or 2 mg daily based upon CYP 2C9 phenotype], only 7% had relapses during treatment and 65% had disease stability, while 48% had adverse events including 20% with elevated enzymes which led to early discontinuation in approximately 5%). 36336685
Kane M. Siponimod therapy and CYP2C9 genotype. 2023 Aug 9. In: Pratt VM, Scott SA, Pirmohamed M, Esquivel B, Kattman BL, Malheiro AJ, editors. Medical genetics summaries [Internet]. Bethesda (MD): National Center for Biotechnology Information (US); 2012–. PMID: 37561888. (Siponimod is metabolized by P450 enzymes predominantly by CYP 2C9, and decreased 2C9 activity can lead to higher levels of siponimod and increased side effects; patients with CYP 2C9*3 heterozygosity should receive a 50% lower dose and those with homozygosity should not take the drug; the effects of other, more rare alleles, are not well defined).
Jiang Y, Lu R, Du Z, Shen Y, Zhou Q, Luan P, Zhu H. The real-world safety assessment of siponimod: a systematic analysis based on the FAERS database. J Neurol Sci. 2025;468:123364.. (Analysis of spontaneous reports of adverse events due to siponimod submitted to the FDA Adverse Event Reporting System [FAERS] between 2019 and 2023 identified 7185 reports including liver test elevations in 144). 39732042
Abbadessa G, Schiavetti I, Bollo L, Cellerino M, Miele G, Zanghì A, Cavalla P, et al; S1PRm study group. Safety assessment of switching from fingolimod to siponimod: an Italian multicenter prospective study. J Neurol Sci. 2025;474:123533.. (Among 95 Italian patients with secondary progressive multiple sclerosis on fingolimod, 42 were switched to siponimod, after which ALT elevations were found in 33% of those switched to siponimod vs 21% remaining on fingolimod, but there were no elevations above 5 times ULN). 40373481
Fox RJ, Cohan S, Mao-Draayer Y, Weinstock-Guttman B, Cruz LA, Arnould S, Cox GM, et al. Safety and tolerability of conversion to siponimod from other disease-modifying therapies in patients with advancing forms of relapsing MS: results from the EXCHANGE study. Mult Scler. 2025;31:706-718.. (Among 185 patients with worsening multiple sclerosis who were switched to siponimod from another disease modifying therapy, 32% reported adverse events, most frequently headache [8%], lymphopenia [7%], fatigue [7%], but ALT elevations only infrequently [2 patients: 1.1%]). 40248858
Woodson S, Gettings EJ, Guo CY, Klineova S, Lee JM, Romero RS, Walker A, et al. Comparative effectiveness of fumarates versus sphingosine-1-phosphate receptor modulators in Black patients with multiple sclerosis. Neurol Ther. 2025;14:1627-1639.. (Analysis of health claim reports identified 1664 Black patients with multiple sclerosis who were treated a fumarate [n=2131] or an S1P receptor modulator [n=433] between 2017 and 2023, the annualized relapse rates were 0.34 vs 0.35 and 75% of patients remained relapse free; no mention of adverse event rates). 40522622
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, one case was attributed to fingolimod and one to natalizumab, but no other agents used to treat multiple sclerosis were listed: personal communication). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Siponimod: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Siponimod/AE)%20AND%20Human%5bMH%5d%20AND%20(drug%20induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver/DE%20OR%20liver%20diseases/CI)%20AND%20(%221900%5C%5C1%5C%5C1%22%5bEDat%5d:%222999%5C%5C12%5C%5C31%22%5bEDat%5d))

2. Trials on Siponimod: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Siponimod)